# Maria and Victorino (M & V) System of Causality Assessment in Drug Induced Liver Injury

The M & V System of assessment of causality in drug induced liver injury was developed by Drs. V.A.J. Maria and R.M.M. Victorino (Faculty of Medicine, Lisbon, Portugal) in an attempt to improve upon the RUCAM system, by addition of other clinical elements and by simplifying and changing the relative weight of elements in the assessment of causality. The major addition of the M & V scoring system compared to RUCAM was the inclusion of points for extrahepatic manifestations of drug induced liver injury.

The M & V system consists of five components with scores given in seven areas.

Component I deals with the temporal relationship between drug intake and the clinical onset and course of liver injury. Three scores (areas IA, IB, and IC) are applied based upon temporal relationships.

A Time of onset of first clinical or laboratory manifestation. Three points are given if onset is 4 days to 8 weeks (or <4 days for reexposure) after starting the medication, whereas 1 point is given for all other times (<4 days or more than 8 weeks). The scores are the same for cholestatic and mixed injury as for hepatocellular forms of injury. Thus, the time to onset scoring is simpler in the M & V than the RUCAM scoring and there are slightly narrower ranges for the higher scores (4 days to 8 weeks compared with 5 to 90 days).
B Time from withdrawal of the drug until onset of manifestations. For patients in whom the liver injury arises after the drug is stopped, 3 points are given for 0 to 7 days, no points for 8 to 15 days, and -3 points for more than 15 days (except for drugs that have prolonged persistence in the body after withdrawal, amiodarone being mentioned as an example). The limits of time from withdrawal to onset of injury are narrower in the M & V system (0 to 7 days) than the RUCAM system (0 to 15 days for hepatocellular, and 0 to 30 days for mixed and cholestatic injury), and the scoring has a wider range (+3, 0, or -3) compared to the RUCAM system (none or +1 points). As with the RUCAM system, it is not clear whether points should be given for both IA and IB, or whether they are mutually exclusive.
C Time from withdrawal of the drug until normalization of laboratory values. The course of injury in the M & V system is defined by withdrawal of the drug rather than peak values as is used in the RUCAM system. Normalization is defined as < twice the upper limit of normal. Three points are given if this is <6 months in cholestatic and mixed forms of injury and if <2 months in hepatocellular forms of liver injury. No points are given if the time to normalization is >2 months for hepatocellular or >6 months for mixed or cholestatic forms of injury. Thus, the scoring for course of the injury is only 0 and 3+ in the M & V system compared to -2, 0, 1+, 2+ or 3+ in the RUCAM system. The scoring and calculation is far simpler in the M & V than the RUCAM system (which requires calculation of a 50% drop in values over 8, 30 or 180 days). On the other hand, the use of “months” and “weeks” as opposed to always using “days” (as in the RUCAM) system is a possible source of confusion (for instance, does 8 weeks constitute 56 days or 60 days and is it the same as 2 months?).

Component II deals with the exclusion of other causes of liver injury. The causes that require exclusion are viral hepatitis (HAV, HBV, HCV, CMV and EBV), alcoholic liver disease, biliary obstruction, preexisting liver disease, and “other” with mention of pregnancy or acute hypotension. Three points are given if all five are excluded, no points are given if there is “partial” exclusion, -1 point if there is another possible alternative cause, and -3 points if another probable cause is detected. This system is somewhat more complex than the RUCAM system and does not allow for lack of exclusion of an unlikely cause (EBV or CMV infection, or absence of a test for IgM anti-HAV) nor the diagnosis of drug induced liver injury in a patient with preexisting liver disease.

Component III deals with extrahepatic manifestations which are defined by rash, fever, arthralgias, eosinophilia (>6%) and cytopenia (anemia, agranulocytosis, thrombocytopenia). This area is given considerable weight in the M & V system, but is not used in the RUCAM system. This area applies largely to immunoallergic forms of drug induced liver injury. Three points are given if there are four or more extrahepatic manifestations, 2 points if there are two or three, 1 point if there is one, and no points if there are no such manifestations. The definition of these manifestations is only vaguely given. Thus, the amount of fever and its documentation, what constitutes a relevant rash, and what represents anemia or thrombocytopenia are not clearly defined.

Component IV relates to rechallenge, either intentional or accidental. Three points are given for a positive rechallenge and no points for a negative or no rechallenge. This scoring is simpler in the M & V than the RUCAM system. A positive rechallenge is defined by a rise of at least twice the upper limit of normal for ALT or alkaline phosphatase, but the timing and degree of rechallenge (dose and duration) are not provided.

Component V relates to previous reports in the literature of cases due to the drug. Two points are given if there are case reports of liver injury due to this drug in the literature; no points are given in the absence of reports in the literature and the drug has been marketed for 5 years or less; and –3 points given if there are no reports in the literature and the drug has been marketed for more than 5 years. This scoring is simpler in the M & V than the RUCAM system, but both are limited by the demands of knowing whether there is at least one case report of injury due to the medication. Most medications are implicated in least one case report of drug induced liver injury, but some of these are of dubious quality or are unconvincing. Thus, drugs such as atropine, theophylline and gentamicin which have been widely used for many years have been linked to liver injury in at least one case report, but in most cases these reports were not particularly convincing, particularly in view of the frequency of their use.

The M & V system does not include scores for risk factors such as age, alcohol use and pregnancy, which are used in the RUCAM system. The M & V system also does not include elements of subtracting points for other medications, whether they are hepatotoxins or not as is done in the RUCAM system. If more than one drug is under suspicion, the M & V system calls for calculation of a score for each drug, and the one with the higher score is considered the most likely involved.

Scores in the M & V system range from –6 to 20, with scores of <6 being considered excluded, 6 to 9 unlikely, 10 to 13 possible, 14 to 17 probable, and >17 definite. These terms for levels of causality are slightly different than used in the RUCAM system, which includes only excluded, unlikely, possible, probable, and highly probable. In direct comparisons, “highly probable” in the RUCAM system is usually interpreted as equivalent to “definite” in the M & V system.

In the initial description of the M & V system, a high degree of correlation was found compared with “expert opinion”, the agreement in 50 cases of drug induced liver injury (some of which were described as “fictitious”) being 84% with a kappa value of 0.90. However, in separate analyses done on 215 cases of drug hepatotoxicity, the M & V system was found to be less reliable than the RUCAM system, with absolute agreement between the two scales in only 18% of cases. Cases rated as definite using the M & V system were largely those with a positive rechallenge. The absence of a classification of definite for cases without a rechallenge was considered consistent with the literature and expert opinion about causality.

The identification of elements used in the M & V system and their relative weights were assigned, based upon expert opinion of the authors and not by prospective evaluation using different elements and different cut points and weights. A similar criticism can be made about the RUCAM system, but the numbers of experts and degree of validation was greater in that consensus panel developed system.

## M & V Causality Assessment Scale

M & V Causality Assessment Worksheet (PDF – 100 KB)

I Temporal Relationship Between Drug Intake and Onset of Clinical Picture | Score
A Time from drug intake until the onset of the first clinical or laboratory manifestations
a 4 days to 8 weeks (or less than 4 days in cases of reexposure | 3
b. Less than 4 days or more than 8 weeks | 1
B. Time from withdrawal of the drug until the onset of manifestations
a 0 to 7 days | 3
b. 8 to 15 days | 0
c. More than 15 days* | -3
C. Time from withdrawal of the drug until normalization of laboratory values**
a Less than 6 months (cholestatic or mixed patterns) or 2 months; (hepatocellular) | 3
b. More than 6 months (cholestatic or mixed) or 2 months (hepatocellular) | 0
II. Exclusion of Alternative Causes
Viral hepatitis (HAV, HBV, HCV, CMV, EBV), alcoholic liver disease, biliary tree obstruction, preexisting liver disease, other (pregnancy, acute hypotension)***
Complete exclusion | 3
Partial exclusion | 0
Possible alternative cause detected | -1
Probable alternative cause detected | -3
III. Extrahepatic Manifestations
Rash, fever, arthralgias, eosinophilia (>6%), cytopenia
4 or more | 3
2 or 3 | 2
1 | 1
None | 0
IV. Intentional or Accidental Reexposure to the Drug
Positive rechallenge test | 3
Negative or absent rechallenge test | 0
V. Previous Report in the Literature of Cases of DILI Associated with Drug
Yes | 2
No (drugs marketed for up to 5 years) | 0
No (drugs marketed for more than 5 years) | -3

* Except cases of prolonged persistence of the drug in the body after drug withdrawal (e.g., amiodarone).

** Normalization = decrease to values below two times the upper limit of normal values.

*** Use the exclusion criteria considered appropriate in each case.

## References

Maria VAJ, Victorino RMM. (1997). Development and validation of a clinical scale for the diagnosis of drug-induced hepatitis. Hepatology. (Original description of the M & V system for assessing drug induced liver injury, including temporal components [time to onset 1 or 3, time from withdrawal -3, 0, or 3, time to recovery 0 or 3, exclusion of other causes -3 to 3, extrahepatic manifestations 0 to 3, rechallenge 0 or 3, and previous reports -3, 0, 2]; testing on 50 cases by 3 experts, agreed with expert opinion in 84%, kappa=0.9).
Danan G, Benichou C. (1993). Causality assessment of adverse reactions to drugs-I. A novel method based on the conclusions of International Consesnsu Meetings: application to drug-induced liver injuries. J Clin Epidemiol. (Description of the RUCAM System, based upon the results of consensus meetings of experts organized by Roussel Uclaf Pharmaceuticals on adverse events, liver events being representative; experts included Drs. Benhamou, Bircher, Dana, Maddrey, Neuberger, Orlani, Tygstrup and Zimmerman. R values were used to define cholestatic, hepatocellular and mixed injury. Time to onset given only 1+ or 2+, course given range of -3 to +3, risk factors 2 points [age, alcohol, pregnancy], other causes to exclude included drugs and other diseases, previous knowledge of toxicity 0, 1+ and 2+, and rechallenge result -3 to +3. A discrepancy exists between Figures 1 and 2 regarding criterion 1 [0 to 3+ vs 1+ or 2+]. Using RUCAM, scores usually agreed, differing in more than 1 point in only 16%).
Benichou C, Danan G, Flahault A. (1993). Causality assessment of adverse reactions to drugs-II. An original model for validation of drug causality assessment methods: case reports with positive rechallenge. J Clin Epidemiol. (Results of using RUCAM on 77 case reports, single agent being implicated in 49; scores ranged from -5 to +13 [potential -5 to +14]; authors introduced the terms “excluded” for scores of < 0, “unlikely” for 1 to 2, “possible” for 3 to 5, “probable” for 6 to 8, and “highly probable” for >8).
Lucena MI, Camargo R, Andrade RJ, Perez-Sanchez CJ, Sanchez De La Cuesta F. (2001). Comparison of two clinical scales for causality assessment in hepatotoxicity. Hepatology. (Comparison of RUCAM to M & V instruments on 215 cases of Spanish registry; the authors found many discrepancies between the two systems, with RUCAM being more discriminating and reliable than M & V).
Aithal PG, Day CP. (1999). The natural history of histologically proved drug induced liver disease. Gut. (Cohort of patients with drug induced liver injury identified in hospital records between 1978-96, and asked to return in follow up 1 to 19 years later; 13 of 33 [39%] had liver test abnormalities and 3 found to have significant abnormalities on liver biopsy; cases were categorized as likely or unlikely using a score of 11 in the M & V system).